# Dicyclomine

## OVERVIEW

### Introduction

Dicyclomine is an anticholinergic agent used to treat gastrointestinal conditions such as acid peptic disease and irritable bowel syndrome. Dicyclomine has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Dicyclomine (dye sye' kloe meen) is synthetic tertiary amine, antispasmotic and anticholinergic agent which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing gastrointestinal secretions and intestinal motility. Dicyclomine has broad activity against muscarinic acetylcholine receptors, but has been used largely for gastrointestinal conditions including peptic ulcer disease and gastrointestinal conditions associated with pain and spasm. Dicyclomine was approved for use in the United States for the treatment of peptic ulcer disease in 1996, but is now more commonly used as an antispasmotic to treat irritable bowel syndrome. Dicyclomine is available in capsules and tablets of 10 and 20 mg generically and under the brand name Bentyl. Oral syrups and solutions for injection are also available. The typical oral dose in adults is 10 to 20 mg four times daily. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, urinary retention, anxiety, restlessness and delusions. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, dicyclomine has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. The metabolism of dicyclomine is not well defined but it is likely metabolized by the liver.

References on the safety and potential hepatotoxicity of anticholinergics are given together in the Overview section on Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Dicyclomine – Generic, Bentyl®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Dicyclomine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Dicyclomine | 77-19-0 | C19-H35-N-O2 | Dicyclomine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Dicyclomine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Dicyclomine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Dicyclomine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Dicyclomine)